# Imetelstat

## OVERVIEW

### Introduction

Imetelstat is an oligonucleotide inhibitor of telomerase used to treat patients with myelodysplastic syndromes with transfusion dependent anemia. Imetelstat is associated with frequent serum aminotransferase elevations during therapy but has not been implicated in cases of clinically apparent liver injury with jaundice.

### Background

Imetelstat (im” e tel’ stat) is a 13 mer synthetic oligonucleotide that binds to the template region of the RNA of human telomerase blocking the enzyme from binding to chromosomal telomers which results in reduction in telomerase length and inhibition of malignant cell proliferation. Patients with myelodysplastic syndromes (MDS) often have elevations in telomerase enzyme levels, and inhibition of telomerase enzyme activity results in a decrease in malignant stem and progenitor cell proliferation and promotes their apoptotic cell death. In a large, randomized placebo-controlled trial in 178 patients with MDS and transfusion dependence, 38% of imetelstat- vs 15% of placebo-treated subjects achieved transfusion independence for at least 8 weeks. In 2024, imetelstat was given approval for therapy of adults with refractory low- to intermediate-risk MDS with transfusion dependence despite erythropoiesis stimulating agents. Therapy may decrease transfusion dependence but has not been shown to induce remissions or prolong survival. Imetelstat is available as a lyophilized powder for suspension in single use vials of 47 mg and 188 mg under the brand name Rytelo. The recommended dose regimen is 7.1 mg per kilogram body weight intravenously (administered over 2 hours) every 4 weeks. Adverse events include infusion reactions, fatigue, arthralgia, myalgia, and headache. Imetelstat is myelosuppressive and decreases in white blood cells and platelets are common and need to be monitored. Less common but potentially severe adverse events include febrile neutropenia, bleeding, anemia, and embryo-fetal toxicity.

### Hepatotoxicity

In prelicensure controlled trials, serum ALT elevations occurred in 43% of imetelstat-treated subjects but also in 37% of placebo recipients, and levels rose above 5 times the upper limit of normal (ULN) in 3.4% with Imetelstat vs 5% with placebo. Elevations in alkaline phosphatase and bilirubin levels also occurred during therapy but rates were similar among those who received placebo. Dose interruptions and discontinuations due to liver test abnormalities were uncommon and occurred at similar rates with therapy as with placebo therapy. Most liver test abnormalities resolved with continued therapy, and no patient developed clinically apparent liver injury with jaundice.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Imetelstat is a synthetic, substituted oligonucleotide that is metabolized to individual nucleotides in cells which would not be likely to be toxic. Metabolism does not depend upon hepatic CYP enzymes. It is not clear whether imetelstat causes shortening of telomers in normal hepatocytes and whether that might be harmful with long term therapy.

### Outcome and Management

Imetelstat has been linked to mild-to-moderate serum enzyme elevations during therapy, but the abnormalities were rarely severe and usually asymptomatic and transient. Discontinuation for serum enzyme elevations is rarely necessary but should be done if the elevations are accompanied by symptoms or jaundice or if ALT elevations are persistently more than 5 times the upper limit of normal (ULN). There is no information on cross sensitivity to liver injury between imetelstat and other growth factors or therapies for MDS.

Drug Class: Hematologic Agents, Myelodysplastic Syndrome Agents

Other Drugs in this Class: Azacitidine, Decitabine, Luspatercept

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Imetelstat – Rytelo®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Imetelstat)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Imetelstat | 868169-64-6 | Oligonucleotide

## ANNOTATED BIBLIOGRAPHY

References updated: 30 September 2024

Abbreviations used: iv, intravenously; MDS, myelodysplastic syndrome.

FDA. Multi-disciplinary Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217779Orig1s000MultidisciplineR.pdf (FDA website including product label and multidiscipline review of data submitted in support of imetelstat approval includes discussion of hepatotoxicity, therapy being associated with increase in ALT elevations [43% vs 37% with placebo] and bilirubin [39% vs 39%], with several patients having concurrent elevations in both, but most abnormalities resolved spontaneously suggesting that most elevations were due to the underlying condition; in preregistration studies, there were no instances of clinically apparent liver injury attributed to therapy).
Tefferi A, Lasho TL, Begna KH, Patnaik MM, Zblewski DL, Finke CM, Laborde RR, et al. A pilot study of the telomerase inhibitor imetelstat for myelofibrosis. N Engl J Med. 2015;373:908-19. (Among 33 patients with high or intermediate risk myelofibrosis treated with imetelstat [9.4 mg/kg iv] every 1 to 3 weeks, remission was induced in 7 [21%] and adverse events were frequent, especially thrombocytopenia and anemia; ALT elevations arose in 27%, AST in 55%, alkaline phosphatase in 36% and bilirubin in 49% of subjects, but most abnormalities were mild and self-limited and there were no instances of clinically apparent liver injury attributable to imetelstat). 26332545
Baerlocher GM, Oppliger Leibundgut E, Ottmann OG, Spitzer G, Odenike O, McDevitt MA, Röth A, et al. Telomerase inhibitor imetelstat in patients with essential thrombocythemia. N Engl J Med. 2015;373: 920-8. (Among 18 patients with essential thrombocytosis treated with imetelstat iv once weekly to lower platelet counts to less than 300,000/μL, a hematologic response occurred in all 18, common adverse events were neutropenia, anemia, headache, and syncope; while ALT elevations arose in 72%, they were above 5 times ULN in only 2 [11%]). 26332546
Mascarenhas J, Komrokji RS, Palandri F, Martino B, Niederwieser D, Reiter A, Scott BL, et al. Randomized, single-blind, multicenter phase II study of two doses of imetelstat in relapsed or refractory myelofibrosis. J Clin Oncol. 2021;39:2881-2892. (Among 107 patients with relapsed or refractory myelofibrosis treated with 2 doses of imetelstat, symptom responses were achieved in 32%, and one year objective responses occurred in 79% and 84%; liver test adverse events occurred in 13%, but there were no instances of clinically apparent drug induced liver injury). 34138638
Santini V. Advances in myelodysplastic syndrome. Curr Opin Oncol. 2021;33:681-6. (Review of the pathogenesis, clinical features, complications, diagnosis, cytogenetics, and therapy of MDS mentions the use of luspatercept as well as telomerase inhibitors and hypomethylating agents). 34474438
Sekeres MA, Taylor J. Diagnosis and treatment of myelodysplastic syndromes: a review. JAMA. 2022;328:872-880. (Concise review of clinical features, natural history, diagnosis, and management of MDS; adverse events are listed in tables but without mention or discussion of ALT elevations or hepatotoxicity). 36066514
Garcia-Manero G. Myelodysplastic syndromes: 2023 update on diagnosis, risk-stratification, and management. Am J Hematol. 2023;98:1307-1325. (Review of the classification of MDS and risk categorization with an update on management including discussion of therapies; no mention of ALT elevations or hepatotoxicity). 37288607
Randall MP, DeZern AE. The management of low-risk myelodysplastic syndromes-current standards and recent advances. Cancer J. 2023;29:152-159. (Review of treatment of low-risk MDS including use of erythropoietin, iron chelation, lenalidomide, luspatercept, imetelstat, and low dose hypomethylating agents; no discussion of hepatotoxicity). 37195771
Platzbecker U, Santini V, Fenaux P, Sekeres MA, Savona MR, Madanat YF, Díez-Campelo M, et al. Imetelstat in patients with lower-risk myelodysplastic syndromes who have relapsed or are refractory to erythropoiesis-stimulating agents (IMerge): a multinational, randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. 2024;403:249-260. (Among 178 patients with lower-risk, relapsed or refractory MDS treated with imetelstat vs placebo once weekly, transfusion independence for at least 8 weeks was achieved in 40% vs 15%, while adverse events more common with imetelstat were neutropenia, anemia and thrombocytopenia as well as headache: ALT elevations occurred in 12% vs 7% but were above 5 times ULN in 3% in both groups and there were no clinically apparent episodes of liver injury). 38048786

## OTHER REFERENCE LINKS

1. Recent References on Imetelstat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Imetelstat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Imetelstat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Imetelstat)